# Ivabradine

## OVERVIEW

### Introduction

Ivabradine is a small molecule inhibitor of the If ion channel which is used to decrease the heart rate in patients with symptomatic heart failure who have a resting heart rate above 70 beats per minute despite optimal doses or intolerance of beta blockers. Ivabradine has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Ivabradine (eye vab' ra deen) is a small molecule inhibitor of the If ion current, a mixed Na+-K+ inward current that is a major determinant of the sinoatrial pacemaker rate. Ivabradine inhibits the If ion current and lowers heart rate but, unlike beta blockers, does not affect cardiac contractility. In large clinical trials in patients with heart failure in normal sinus rhythm, ivabradine lowered heart rate and decreased episodes of worsening of heart failure and need for hospitalization. Ivabradine was approved for use in the United States in 2015, the indications limited to patients with symptomatic heart failure (ejection fraction 35% or less) in normal sinus rhythm with heart rate above 70 beats per minute despite maximal doses of beta blockers (or contraindications to their use). Ivabradine is available in tablets of 5 and 7.5 mg under the brand name Corlanor. The recommended dose is 5 to 7.5 mg twice daily. Common side effects include bradycardia, hypertension, atrial arrhythmias, dizziness, and blurred vision. Uncommon, but potentially more severe adverse reactions include atrial fibrillation, heart block, syncope, rash, angioedema and fetal toxicity.

### Hepatotoxicity

In large preregistration clinical trials, similar proportions of patients taking ivabradine as taking placebo developed ALT elevations [15% vs 17%] while ALT elevations above 5 times the upper limit of normal were uncommon [<1%]. Since its approval and more widespread use, there have been no published cases of liver injury attributable to ivabradine. The product label for ivabradine does not mention hepatotoxicity, but cautions against its use in patients with severe, preexisting liver disease.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which ivabradine might cause liver injury is not clear. It is extensively metabolized in the liver largely via CYP 3A4 and is susceptible to drug-drug interactions. Inhibitors of CYP 3A4 cause increase the ivabradine levels, while inducers (such as rifampin) cause reduced serum levels of ivabradine.

### Outcome and Management

The serum enzyme elevations that have occurred during ivabradine therapy have been mild and rapidly reversible, often without withdrawal of the agent. Ivabradine has not been linked to cases of acute hepatitis, liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no evidence that there is cross sensitivity to hepatic injury between ivabradine and other oral antiangina or antiarrhythmic agents.

Drug Class: Antiarrhythmic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ivabradine – Corlanor®

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ivabradine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Ivabradine | 155974-00-8 | C19-H27-N3-O5-S2 | Ivabradine Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 April 2017

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 639-71. (Expert review of hepatotoxicity published in 1999 before the availability of ivabradine).
De Marzio DH, Navarro VJ. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 519-40. (Review of hepatotoxicity of cardiovascular drugs; ivabradine is not discussed).
Maron BA, Rocco TP. Pharmacotherapy of congestive heart failure. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 789-813. (Textbook of pharmacology and therapeutics; ivabradine is not discussed).
Fox K, Ford I, Steg PG, Tendera M, Ferrari R; BEAUTIFUL Investigators. Ivabradine for patients with stable coronary artery disease and left-ventricular systolic dysfunction (BEAUTIFUL): a randomised, double-blind, placebo-controlled trial. Lancet 2008; 372 (9641): 807-16. (Among 10,917 patients with coronary heart disease and left ventricular ejection fractions less than 40% who were treated with ivabradine vs placebo for an average of 19 months, there were no differences in rates of the primary composite cardiovascular endpoint and no differences in serious adverse event rates between the two groups, while common adverse events from ivabradine were bradycardia and blurred vision; no mention of ALT elevations or hepatotoxicity). 18757088
Swedberg K, Komajda M, Böhm M, Borer JS, Ford I, Dubost-Brama A, Lerebours G, et al.; SHIFT Investigators. Ivabradine and outcomes in chronic heart failure (SHIFT): a randomised placebo-controlled study. Lancet 2010; 376 (9744): 875-85. (Among 6558 patients with chronic heart failure in normal sinus rhythm who were treated with ivabradine vs placebo, there were fewer cardiovascular deaths and admissions for heart failure in ivabradine treated patients, and serious adverse events overall were fewer, but side effects more frequent with ivabradine were bradycardia, dizziness and visual disturbances; no mention of ALT elevations or hepatotoxicity). 20801500
Fox K, Ford I, Steg PG, Tardif JC, Tendera M, Ferrari R; SIGNIFY Investigators. Ivabradine in stable coronary artery disease without clinical heart failure. N Engl J Med 2014; 371: 1091-9. (Among 19,102 patients with stable coronary artery disease without heart failure who were treated with ivabradine or placebo for a median of 28 months, there were no differences in cardiovascular endpoints or mortality, and adverse events were more frequent with ivabradline including bradycardia, atrial fibrillation and "phosphenes" [seeing light without light actually entering the eye]; no mention of ALT elevations or hepatotoxicity). 25176136
Ivabradine (Corlanor) for heart failure. Med Lett Drugs Ther 2015; 57 (1469): 75-6. (Concise review of the mechanism of action, clinical efficacy, safety and costs of ivabradine shortly after its approval for use in the US; mentions common adverse events and its potential for drug interactions with CYP 3A4 inhibitors or inducers, but does not mention ALT elevations or hepatotoxicity). 25989196

## OTHER REFERENCE LINKS

1. Recent References on Ivabradine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Ivabradine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Ivabradine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Ivabradine)